# Dimercaprol

## OVERVIEW

### Introduction

Dimercaprol, or British anti-Lewisite (BAL), is a parenterally administered heavy metal chelating agent that is used to treat arsenic, gold, copper and mercury poisoning. Dimercaprol has not been associated with serum enzyme elevations during therapy or with cases of clinically apparent liver injury with jaundice, but its general use has been quite limited.

### Background

Dimercaprol (dye” mer cap’ rol) is a parenterally administered heavy metal chelating agent which has been used to treat arsenic, copper, gold, lead and mercury poisoning as well as severe cases of Wilson disease. Dimercaprol was developed at Oxford University during World War II as a means of treating and reversing poisoning from Lewisite, an arsenical gas used in chemical warfare (and thus initially called British anti-Lewisite [BAL]). Dimercaprol is a simple propranol molecule with two sulfhydryl groups that acts by binding heavy metals, and thus competing and blocking the binding of the toxic metals to sulfhydryl containing metabolic enzymes. Dimercaprol binds mercury, lead, copper, gold and arsenic, and its major current indications are for poisoning with arsenic, gold and mercury and, in combination with EDTA-calcium, acute lead poisoning. In addition, dimercaprol has been used to chelate copper in patients with Wilson disease, but now has been replaced by better tolerated oral chelating agents such as penicillamine and trientine. Dimercaprol is occasionally used in the initial treatment of severe, symptomatic Wilson disease, but generally for a short time only. Dimercaprol is available in solution in oil in ampules of 300 mg (100 mg/mL) generically and under the name BAL. The recommended dose and regimen vary by indication, but are in the range of 2.5 to 5 mg/kg two to five times daily, given by deep intramuscular injection for 2 to 10 days. Dimercaprol is not indicated and may be harmful in iron, cadmium and selenium poisoning. Side effects include injection site reactions, local pain and sterile abscesses as well as systemic symptoms such as nausea, vomiting, headache, dizziness, spasms, sweating, excessive lacrimation or salivation, and skin or body tingling, burning and pain. Rare, but potentially severe adverse events include seizures, stupor and coma.

### Hepatotoxicity

In clinical trials conducted in children with Wilson disease, serum aminotransferase levels generally improved or were stable during treatment with dimercaprol. There have been no clinical reports of acute liver injury with jaundice attributed to dimercaprol. Patients with Wilson disease typically have mild-to-moderate serum aminotransferase elevations and may have signs and symptoms of cirrhosis. Improvement in liver injury in Wilson disease typically requires months to years of treatment. The apparent lack of hepatotoxicity of dimercaprol may be due to the infrequency of its use, the typically short courses of therapy and the prominence of other side effects that limit its more prolonged administration.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Chelating Agents, Wilson Disease Agents

Other Drugs in the Subclass, Wilson Disease: Penicillamine, Trientine, Zinc

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dimercaprol – Generic, BAL®

DRUG CLASS

Chelating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dimercaprol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Dimercaprol | 59-52-9 | C3-H8-O-S2 | Dimercaprol structure

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; dimercaprol is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; chelating agents are not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-6. (Textbook of pharmacology and therapeutics).
Denny-Brown D, Porter H. The effect of BAL(2,3-dimercaptopropanol) on hepatolenticular degeneration(Wilson's disease). N Engl J Med 1951; 245: 917-25. (Studies of 5 patients with Wilson disease and neurologic complications treated with multiple 24 hour courses of intramuscular BAL found marked improvement in tremor and rigidity and increase in cupruresis). 14882450
Dimercaprol for hepatolenticular degeneration. Lancet 1952; 1 (6700): 199-200. (Initially used as an antidote for wartime arsenical gas poisoning, BAL was then found to increase excretion of other metals, and later shown to improve symptoms of Wilson disease, to increase urinary excretion of copper 2 to 7 times, and to not worsen liver disease). 14889814
Warnock CG, Neill DW. Dimercaprol in the pre-neurological stage of Wilson's disease(hepatolenticular degeneration). J Neurol Neurosurg Psychiatry 1954; 17: 70-4. (Treatment of a 12 year old child with Wilson disease [of which two siblings had died], without neurologic symptoms, with multiple courses of BAL showed marked increase in copper excretion and improvement in liver disease). 13131080
Bearn AG. The place of BAL in the therapy of Wilson.s disease. Am J Med 1956; 21: 134. Not in PubMed (Among patients with Wilson disease treated with BAL in doses of 200 to 300 mg twice daily for several months, injections were often painful and toxic reactions included high fever, worsening of neurologic signs, hallucinations, delirium and coma).
Walshe JM. Penicillamine, a new oral therapy for Wilson's disease. Am J Med 1956; 21: 487-95. (Initial studies on efficacy of oral penicillamine [β,β-dimethyl cysteine, a monothiol] in inducing cupruresis in Wilson disease, and lack of effect of cysteine and methionine; no toxic reactions were observed). 13362281
Vilensky JA, Redman K. British anti-Lewisite (dimercaprol): an amazing history. Ann Emerg Med 2003; 41: 378-83. (History of development and use of dimercaprol, initially synthesized at Oxford during WWII as a means of reversing Lewisite arsenical gas poisoning [thus British anti-Lewisite (BAL)] and now still used for emergency therapy of heavy metal poisoning by arsenic, gold, copper and mercury). 12605205
Ala A, Walker AP, Ashkan K, Dooley JS, Schilsky ML. Wilson's disease. Lancet 2007; 369 (9559): 397-408. (Review of the clinical features, pathogenesis, genetics, diagnosis and treatment). 17276780
Roberts EA, Schilsky ML, AASLD. Diagnosis and treatment of Wilson disease: an update. Hepatology 2008; 47: 2089-111. (Thorough review of the cause, natural history, diagnosis and treatment of Wilson disease with specific recommendations for use of penicillamine, trientine and zinc). 18506894
Walshe JM. The conquest of Wilson's disease. Brain 2009; 132 (Pt 8): 2289-95. (History of the initial description of Wilson disease, its link to copper accumulation, and therapies several of which were developed by the author). 19596747
Weiss KH, Stremmel W. Evolving perspectives in Wilson disease diagnosis: treatment and monitoring. Curr Gastroenterol Rep 2012; 14: 1-7. (Review of the diagnosis and management of Wilson disease, including the role of genetic testing and the choice of medical therapies). 22083169
Breuer C, Oh J, Nolkemper D, Achilles EG, Fischer L, Eglite I, Guesmer C, Heitland P, et al. Successful detoxification and liver transplantation in a severe poisoning with a chemical wood preservative containing chromium, copper, and arsenic. Transplantation 2015; 99: e29-30. (4 year old boy ingested wood preservative [chromium, copper and arsenic] and presented with nausea and vomiting followed by renal and hepatic failure, requiring parenteral dimercaprol before and for 3 months after liver transplantation). 25827325
Chakor RT, Bharote H, Eklare N, Tamboli K. Unilateral rubral tremors in Wilson's disease treated with dimercaprol. Ann Indian Acad Neurol 2015; 18: 115-6. (22 year old man with Wilson disease and severe tremors not relieved by penicilliamine, responded within a month to a course of dimercaprol; no mention of ALT levels or liver injury). 25745328
Permar S, Gorman K, Lercher D, Bradford KK. Rare etiology of abdominal pain in an adolescent female. Clin Pediatr (Phila) 2015; 54: 94-7. (16 year old female developed abdominal pain, hematemesis, anemia and liver test abnormalities [bilirubin 1.4 mg/dL, ALT 81 U/L, AST 70 U/L, Alk P 55 U/L, hematocrit 26.8% with basophilic stippling], found to have lead poisoning from drinking out of locally made terra cotta pottery bought in Mexico; treated with dimercaprol and EDTA). 25015930
Shumy F, Anam AM, Kamruzzaman AK, Amin MR, Chowdhury MA. Acute arsenic poisoning diagnosed late. Trop Doct 2016; 46: 93-6. (17 year old Indian man developed nausea, vomiting and progressive flacid paralysis followed by jaundice and coma [bilirubin 10.3 mg/dL, ALT 160] due to arsenic poisoning, responding with slow improvement to a 10 day course of dimercaprol). 26508422
Grasso IA, Blattner MR, Short T, Downs JW. Severe systemic lead toxicity resulting from extra-articular retained shrapnel presenting as jaundice and hepatitis: a case report and review of the literature. Mil Med 2017; 182: e1843-e1848. (31 year old soldier with history of gunshot wound developed abdominal pain and jaundice, but normal ALT levels despite liver biopsy showing steatohepaittis; evaluation of anemia demonstrated lead poisoning, that responded partially to several courses of dimercaprol, but eventually required surgical removal of shrapnel in leg). 28290970

## OTHER REFERENCE LINKS

1. Recent References on Dimercaprol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dimercaprol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dimercaprol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dimercaprol)